# Ketoprofen

## OVERVIEW

### Introduction

Ketoprofen is a nonsteroidal antiinflammatory drug (NSAID) used in the treatment of acute pain and chronic arthritis. Ketoprofen has been linked to a low rate of serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Ketoprofen (kee" toe proe' fen) belongs to the propionic derivative class of NSAIDs similar to naproxen, fenoprofen, and ibuprofen. Like other NSAIDs, ketoprofen is a cyclo-oxygenase (Cox-1 and -2) inhibitor that blocks the formation of proinflammatory prostaglandins that are important in pain and inflammatory pathways. Ketoprofen has analgesic as well as antipyretic and antiinflammatory activities. Ketoprofen was approved in the United States in 1986 and is still used although it is one of the least frequently prescribed NSAIDs. Current indications include chronic joint pain due to osteoarthritis and rheumatoid arthritis as well as mild-to-moderate acute pain and dysmenorrhea. Ketoprofen is available by prescription in the form of capsules or tablets of 25, 50 and 75 mg in both generic and trade formulations (Orudis, Oruvail, among others). The recommended dose in adults with chronic arthritis is 50 to 75 mg 3 or 4 times per day with a maximum dose of 300 mg daily. Extended release formulations of 100, 150 and 200 mg are also available for once daily dosing, the maximum daily dose being 200 mg. Ketoprofen is also available in some countries in over-the-counter formulations of 12.5 mg tablets for treatment of mild-to-moderate pain and dysmenorrhea. As with other NSAIDs, ketoprofen is generally well tolerated, but side effects can include headache, dizziness, somnolence, gastrointestinal upset, nausea, abdominal discomfort, diarrhea, peripheral edema and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as ketoprofen include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, fetal toxicity, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Prospective studies show that 1% to 2% of patients taking ketoprofen experience at least transient serum aminotransferase elevations. These may resolve even with drug continuation. Marked aminotransferase elevations (>3 fold elevated) occur in <1% of patients. Clinically apparent liver injury with jaundice from ketoprofen is very rare and only individual case reports have been published. The latency to onset has been rapid, often within a few days of starting. The pattern of enzyme elevations has ranged from cholestatic to hepatocellular. Immunoallergic features are present in some cases (low grade fever, rash), but are generally not prominent, and autoantibody formation is rare. Most cases resolve promptly on stopping therapy. Ketoprofen is not mentioned in large case series on drug induced liver injury or acute liver failure. Fewer than a dozen case reports of liver injury due to ketoprofen have been published.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of ketoprofen hepatotoxicity is not known, but likely to be due to an idiosyncratic reaction to an intermediate of its metabolism. Ketoprofen is extensively metabolized by the liver.

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels, to symptomatic hepatitis with or without jaundice. A single case of fulminant hepatitis possibly due to ketoprofen has been reported, but death appeared to be due to complications of pancreatitis and renal insufficiency. Patients with ketoprofen induced liver injury should avoid other propionic acid derivatives such as naproxen and ibuprofen.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Acute hepatocellular injury and jaundice arising within a few days of starting ketoprofen.(1)

A 23 year old woman developed abdominal pain and nausea 2 days and jaundice 4 days after starting ketoprofen for low back pain. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Her only other medication was birth control pills. Physical examination was normal except for jaundice; there was no fever, rash or hepatomegaly. Laboratory tests showed serum bilirubin of 2.9 mg/dL with marked elevations in serum aminotransferase levels (ALT~30 times ULN, AST~14 times ULN) and normal alkaline phosphatase (Table). There was no eosinophilia. Tests for hepatitis A, B, C and E were negative as were autoantibodies. A liver biopsy showed hepatic necrosis and inflammation, mild cholestasis, and prominence of eosinophils in portal areas. Stopping ketoprofen was followed by rapid improvement. She remained on birth control pills.

#### Key Points

Medication: | Ketoprofen (200 mg extended release once daily for 4 days)
Pattern: | Hepatocellular (R=30)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 days to symptoms, 4 days to jaundice
Recovery: | Complete recovery 2 months after stopping
Other medications: | Combination estrogen and progesterone birth control pill

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | Ketoprofen given for low back pain
4 days | 0 | 1260 | Normal | 3.2 | Ketoprofen stopped
8 days | 4 days | 1218 | | 5.6
12 days | 8 days | 1134 | | 7.7 | Liver biopsy
24 days | 3 weeks | 378 | | 5.4 | Discharged
10 weeks | 10 weeks | 40 | Normal | 0.5
Normal Values | | < 42 | | < 1.2

*ALT values were calculated based upon upper limit of normal values; bilirubin levels were converted from µmol/L to mg/dL.

#### Comment

The rapid appearance of hepatic injury suggests a hypersensitivity reaction, but most cases of ketoprofen induced hepatotoxicity have not been accompanied by fever, rash or eosinophilia. Whether there is cross reactivity with other NSAIDs of similar structure (ibuprofen, naproxen) is unknown. Ketoprofen is widely used and hepatotoxicity is exceedingly rare.

### Case 2. Cholestatic liver injury arising within a few days of starting ketoprofen.(2)

A 49 year old man developed fever, malaise and abdominal pain after 2 days and jaundice after 4 days of ketoprofen therapy for renal colic. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. His other medications included aminopyrine and tiemonium which were started at the same time as ketoprofen. Physical examination was normal. Laboratory tests showed elevations in serum bilirubin with only mild increases in ALT and alkaline phosphatase (Table). There was no eosinophilia. Tests for hepatitis A, B, and C were negative as were routine autoantibodies. Ultrasound of the abdomen showed no abnormalities of the liver or biliary tract. Stopping ketoprofen was followed by rapid improvement.

#### Key Points

Medication: | Ketoprofen (200 mg extended release once daily for 4 days)
Pattern: | Cholestatic (R=1.3)
Severity: | 3+ (jaundice, hospitalization prolonged)
Latency: | 2 days to symptoms, 4 days to jaundice
Recovery: | Complete recovery 2 months after stopping
Other medications: | Aminopyrine, tiemonium (antispasmodic)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 21 | 68 | 0.7 | Ketoprofen started
4 days | 0 | 82 | 142 | 3.6 | Ketoprofen stopped
7 days | 3 days | 73 | 186 | 1.8
3 weeks | 16 days | 19 | 173 | 1.1
6 weeks | 5 weeks | 40 | 117 | 0.9
3 months | 3 months | 25 | 75 | 0.6
Normal Values | | <40 | <90 | <1.2

#### Comment

The similarity to Case 1 in latency of onset was striking, but the enzyme pattern was quite different, with minimal increases in ALT and alkaline phosphatase rather than a marked ALT evaluations and hepatocellular pattern. These two cases suggest that latency to onset may be more reliable as a “signature” of the drug induced liver injury than pattern of enzyme elevation. However, there have been too few cases of ketoprofen induced liver injury described to provide a clear characterization of its patterns of enzyme elevations and clinical phenotype.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ketoprofen – Generic, Orudis®, Oruvail®

DRUG CLASS

Antiinflammatory Agents, Nonsteroidal

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ketoprofen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ketoprofen | 22071-15-4 | C16-H14-O3

## CITED REFERENCES

1 Bonaventure C, Nancey S, Pont E, Michalet V, Chevalier M, Vial T, Taieb S, et al. [Ketoprofen-induced acute hepatitis]. Gastroenterol Clin Biol 2001; 25: 716-7. French. 11673741
2 Rambaud S, Nores JM, Rémy JM. [Jaundice related to the ingestion of ketoprofen]. Ann Med Interne (Paris) 1990; 141: 278. French. 2369020

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2025

Abbreviations used: NSAIDs, nonsteroidal antiinflammatory drugs

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999; ketoprofen is listed as having a very low rate of hepatic injury).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401.
(Review of hepatotoxicity of NSAIDs mentions that a few cases of hepatotoxicity from ketoprofen have been reported).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Wollheim FA, Lindroth Y, Sjoblom KG. A comparison of ketoprofen and naproxen in rheumatoid arthritis. Rheumatol Rehabil 1978; Suppl: 78-83. PMID: (Double-blind, cross over study of 4 week courses using different doses of ketoprofen vs naproxen in 30 patients with rheumatoid arthritis; common side effects were abdominal pain, dyspepsia, nausea, headache and pruritus; but "no abnormalities were found in... liver function tests"). 364615
Gross W. Long-term studies on therapy and tolerance of ketoprofen. Rheumatol Rehabil 1978: Suppl: 112-3. (Among 33 patients given ketoprofen and 32 given indomethacin for 5 months, analgesic effect was good with both and there were "no significant differences... on the parameters of liver or renal function"). 364601
Llorca G, Larbre JP, Collet Ph, Ravault A, Lejeune E. Changing the class of NSAID in cases of hepatotoxicity. Ann Rheum Dis 1988; 47: 791. (44 year old man with ankylosing spondylitis developed mild Alk P elevations [144 U/L] and eosinophilia [9%] 2 months after starting diclofenac with normal ALT [9 U/L] and bilirubin [0.4 mg/dL]; abnormalities resolved rapidly on stopping diclofenac and did not reappear after switching to ketoprofen). 3178321
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive review of NSAID related liver injury states that ketoprofen appears "not to have been incriminated in hepatic disease"). 2281340
Rambaud S, Nores JM, Rémy JM. [Jaundice related to the ingestion of ketoprofen] Ann Med Interne (Paris) 1990; 141: 278. French. PMID: 2369020 (49 year old man developed symptoms after 2 and jaundice after 4 days of ketoprofen therapy [bilirubin 3.6 mg/dL, ALT 82 U/L, Alk P 186 U/L], resolving within 5 weeks of stopping: Case 2).
Nores JM, Rambaud S, Remy JM. Acute hepatitis due to ketoprofen. Clin Rheumatol 1991; 10: 215-6. (Same case as in Rambaud [1990], but in English). 1914425
Dutertre J-P, Bastides F, Jonville A-P, De Muret A, Sonneville A, Larrey D, Autret E. Microvesicular steatosis after ketoprofen administration. Eur J Gastroenterol Hepatol 1991; 3: 953-4. Not in PubMed (47 year old man with rheumatoid arthritis developed abnormal Alk P [159 U/L] and GGT [145 U/L] without symptoms 2 weeks after starting ketoprofen that persisted and rose until ketoprofen was stopped 1 month later, resolving in 2 months; liver biopsy showed microvesicular steatosis).
Walker AM. Quantitative studies of the risk of serious hepatic injury in persons using nonsteroidal antiinflammatory drugs. Arthritis Rheum 1997; 40: 201-8. (Review of population based studies of NSAID use and hepatic injury; frequency of clinically apparent liver injury from NSAIDs overall was ~10 cases per 100,000 patient-years of use; ketoprofen reported in one study as 17 per 100,000 [2 cases among 14,457 person-years of risk]). 9041931
Flamenbaum M, Abergel A, Marcato N, Zénut M, Kémény JL, Cassan P. [Regressive fulminant hepatitis, acute pancreatitis and renal insufficiency after taking ketoprofen]. Gastroenterol Clin Biol 1998; 22: 975-6. (73 year old man developed vomiting and abdominal pain after 2 days and jaundice after 5 days of starting rectal ketoprofen [bilirubin 29.4 mg/dL, ALT 148 U/L, Alk P 1430 U/L], resolving upon stopping; patient also had pancreatitis and renal insufficiency; mental confusion was attributed to hepatic encephalopathy). 9881281
Bonaventure C, Nancey S, Pont E, Michalet V, Chevalier M, Vial T, Taieb S, et al. [Ketoprofen-induced acute hepatitis] Gastroenterol Clin Biol 2001; 25: 716-7. French. PMID: 11673741 (23 year old woman developed nausea after 2 days and jaundice after 4 days of ketoprofen therapy [bilirubin 2.9 mg/dL, ALT 30 times ULN, Alk P normal], resolving within 2 months of stopping: Case 1).
Mété D, Milon A, Belon G, Gatina JH. [Acute pancreatitis and ketoprofen] Gastroenterol Clin Biol 2001; 25: 721-2. French. PMID: 11673744 (35 year old man developed pancreatitis without jaundice or liver tests abnormalities 2 months after starting ketoprofen [lipase 1255 U/L], with no other cause identified and normal endoscopic retrograde cholangiopancreatography).
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL; Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG); General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol 2004; 18: 201-6. (Case controlled study of patients presenting with suspected drug induced liver injury in a general practice context in Southern France found 88 cases which were matched with 178 controls; 22 cases vs 16 controls had been exposed to NSAIDs; 5 diclofenac, 4 ibuprofen, 4 ketoprofen, 2 niflumic acid, 1 flurbiprofen and 1 meloxicam, rest to salicylates which were as frequently used in controls as cases; there were no fatalities and cases were more common in women than men). 15066135
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. (NSAIDs are the most commonly used drugs in the US and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4/100,000 patient-years of NSAID use [1 case per 4,500 persons exposed] and deaths from liver injury occurred in ~1/100,000 patient-years; frequency of injury did not increase with age and was no more common in women than men; in case controlled studies, higher odds ratio for liver injury was found with sulindac, indomethacin, piroxicam and diclofenac; no mention of ketoprofen). 15298630
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Survey of all cases of fatal drug induced liver injury from Swedish Adverse Drug Reporting system from 1966-2002; among 103 cases, none were attributed to ketoprofen). 16165719
Lapeyre-Mestre M, de Castro AM, Bareille MP, Garcia del Pozo J, Requejo AA, Arias LM, Montastruc J-L, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; ketoprofen listed as associated with 4 of 2114 [0.2%] hepatic reactions from Spain and 429 of 27,372 [1.5%] from France; details of injury not given). 16867024
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verman A, Rothman K. Use of cyclo-oxygenase 2 inhibitors (COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15: 861-72. (Surveys from the UK and USA indicate that ibuprofen, naproxen and diclofenac were the most commonly used NSAIDs; ketoprofen not in top 10 agents used). 17086563
Zabala S, Calpe MJ, Pérez G, Lerín FJ, Mouronval L. Neutropenia, thrombocytopenia and hepatic injury associated with dexketoprofen trometamol therapy in a previously healthy 35-year-old woman. J Clin Pharm Ther 2008; 33: 79-81. (35 year old woman developed fever 5 days after starting dexketoprofen [active enantiomer of racemic ketoprofen, available in UK] and stopped at ten days [bilirubin 0.5 mg/dL, ALT 216 U/L, Alk P 105 U/L], with low platelet [94,000/μL] and white cell counts [1,600/μL] and resolution within 2 weeks of stopping). 18211621
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; none were attributed to ketoprofen). 18955056
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; no discussion of ketoprofen). 21128314
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 7 to NSAIDs, including 4 to bromfenac, 2 diclofenac and 1 etodolac, but none to ketoprofen, ibuprofen or naproxen). 20949552
Famularo G, Gasbarrone L, Minisola G. Probable ketoprofen-associated nonalcoholic fatty liver disease and steatohepatitis. Ann Pharmacother 2011; 45: 423. (45 year old woman developed abdominal pain and fever 5 days after starting ketoprofen [bilirubin 2.8 mg/dL, ALT 612 U/L, Alk P 810 U/L, without eosinophilia], resolving within 1 week of stopping; she had tolerated diclofenac and ketorolac in the past). 21364038
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Among 600 patients undergoing liver transplantation for acute liver failure at 52 European liver transplant centers between 2005 and 2007, 301 were considered idiopathic and had received a medication within 30 days of onset, including acetaminophen in 192 and NSAIDs in 40, including ketoprofen in 3 for a rate of 1.55 per million-treatment years). 23325533
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Association Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of serious adverse events reporting to a French pharmacovigilance database found highest cumulative rates for liver related reports for nimesulide [0.15 per million defined daily doses], followed by diclofenac [0.09], ketoprofen [0.09], piroxicam [0.06], naproxen [0.04] and meloxicam [0.03], being significant in case/noncase analyses for nimesulide, diclofenac and piroxicam only). 21929527
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac (ranking 2nd), but none due to ketoprofen). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; ketoprofen was not listed]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, but none to ketoprofen [Schmeltzer 2016]). 25754159
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, most commonly diclofenac; none were attributed to ketoprofen). 26601797
Donati M, Conforti A, Lenti MC, Capuano A, Bortolami O, Motola D, Moretti U, et al; DILI-IT Study Group. Risk of acute and serious liver injury associated to nimesulide and other NSAIDs: data from drug-induced liver injury case-control study in Italy. Br J Clin Pharmacol 2016; 82: 238-48. (Among 179 cases of acute liver injury and 1770 controls admitted to 9 Italian hospitals between 2010 and 2014, NSAIDs used more frequently in cases compared to controls included nimesulide [17% vs 10%: odds ratio 1.88] and ibuprofen [14% vs 10%: odds ratio 1.59] whereas ketoprofen was being taken at a similar rate by cases [11%] as controls [10%]). 26991794
Zoubek ME, González-Jimenez A, Medina-Cáliz I, Robles-Díaz M, Hernandez N, Romero-Gómez M, Bessone F, et al. High Prevalence of ibuprofen drug-induced Liver injury in Spanish and Latin-American registries. Clin Gastroenterol Hepatol 2018; 16: 292-294. (Analysis of a Spanish and Latin-American registries identified 73 cases of NSAID induced liver injury, the most common agents being nimesulide [38%], diclofenac [34%] and ibuprofen [17%]; ketoprofen was not mentioned). 28782674
Moore N, Scheiman JM. Gastrointestinal safety and tolerability of oral non-aspirin over-the-counter analgesics. Postgrad Med. 2018;130:188-199.. (Review of the gastrointestinal and hepatic safety of over-the-counter analgesics including ketoprofen mentions that liver injury from NSAIDs is quite rare, the risk of hospitalization for liver injury being 3.1-23.4 cases per 100,000 patient years). 29417856
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen, and aspirin and that rare instances of idiosyncratic acute hepatitis attributed to celecoxib have been described; ketoprofen not discussed). 29469052
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623.. (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib). 29568654
Gulmez SE, Unal US, Lassalle R, Chartier A, Grolleau A, Moore N. Risk of hospital admission for liver injury in users of NSAIDs and nonoverdose paracetamol: Preliminary results from the EPIHAM study. Pharmacoepidemiol Drug Saf. 2018;27:1174-1181.. (In a case-population controlled study of a French hospitalization claims database, 63 cases of acute liver injury were identified, 13 of which had been exposed to an NSAID including 6 to diclofenac, 4 to ibuprofen, and 3 to ketoprofen, representing 48, 19, and 21 cases per million users). 30112779
Atzeni F, Masala IF, Bagnasco M, Lanata L, Mantelli F, Sarzi-Puttini P. Comparison of efficacy of ketoprofen and ibuprofen in treating pain in patients with rheumatoid arthritis: a systematic review and meta-analysis. Pain Ther. 2021;10:577-588.. (Systematic review of 4 randomized controlled trials comparing ketoprofen and ibuprofen in managing pain in 456 patients’ chronic arthritis, found that ketoprofen was more effective in control of pain and that adverse event rates and tolerability were similar; no specific mention of ALT elevations or hepatotoxicity). 33674957
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to etodolac and meloxicam, 2 to oxaprozin, and 1 to naproxen and sulindac, but none to ketoprofen). 38451034
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 458 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide, and 11 [2.4%] to ibuprofen and 1 case each to celecoxib, ketoprofen, ketorolac, meloxicam, and piroxicam [personal communication]). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Ketoprofen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ketoprofen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Ketoprofen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ketoprofen)